# Sertraline

## OVERVIEW

### Introduction

Sertraline is a selective serotonin reuptake inhibitor (SSRI) used in the therapy of depression, anxiety disorders and obsessive-compulsive disorder. Sertraline therapy can be associated with transient asymptomatic elevations in serum aminotransferase levels and has been linked to rare instances of clinically apparent acute liver injury.

### Background

Sertraline (ser' tra leen) is a selective serotonin reuptake inhibitor (SSRI) that acts by blocking the reuptake of serotonin in CNS synaptic clefts, thus increasing serotonin levels in the brain which is associated with its psychiatric effects. Sertraline was approved for use in the United States in 1991, and it remains in wide use, with almost 40 million prescriptions being filled yearly. Indications for sertraline include major depression, obsessive-compulsive disorder, panic disorder, and major anxiety disorders including social anxiety, post-trauma stress and generalized anxiety disorder. Sertraline is also used for headache, premenstrual dysphoric disorder, diabetic neuropathy and premature ejaculation. Sertraline is available as tablets of 25, 50 and 100 mg and as an oral suspension in multiple generic forms and under the brand name of Zoloft. The recommended dosage for depression in adults is 50 or 100 mg once daily, increasing the dosage by 25 or 50 mg increments to a maximum of 200 mg. Common side effects are drowsiness, dyspepsia, nausea, headache, increased sweating, increased appetite, weight gain and sexual dysfunction. Rare but potentially severe adverse events include suicidal ideation and behavior, activation of mania, serotonin syndrome, discontinuation syndrome, increased risk of bleeding, seizures, acute glaucoma, hypersensitivity reactions and embryo-fetal toxicity.

### Hepatotoxicity

Liver test abnormalities have been reported to occur in up to 1% of patients on sertraline, but elevations are usually modest and infrequently require dose modification or discontinuation. Rare instances of acute, clinically apparent episodes of liver injury with marked liver enzyme elevations with or without jaundice have been reported in patients on sertraline. The onset of injury is usually within 2 to 24 weeks and the pattern of serum enzyme elevations has varied from hepatocellular to mixed and cholestatic. Autoimmune (autoantibodies) and immunoallergic features (rash, fever, eosinophilia) are uncommon. Acute liver failure due to sertraline has been described but is very rare.

Likelihood score: B (likely but rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which sertraline causes liver injury is not known. Sertraline is metabolized at least in part by the liver, mainly via the cytochrome P450 system and PYP 2D6 and 2B6 which can cause drug-drug interactions. The hepatotoxicity of sertraline may be mediated by toxic intermediates of its metabolism.

### Outcome and Management

The serum aminotransferase elevations that occur on sertraline therapy are usually self-limited and do not require dose modification or discontinuation of therapy. Rare instances of acute liver failure have been attributed to sertraline therapy. Rechallenge usually results in recurrence of liver injury and should be avoided. Persons with intolerance to sertraline may have similar reactions to other SSRIs and careful monitoring is warranted if other such agents are used.

Drug Class: Antidepressant Agents

Other Drugs in the Subclass, SNRIs/SSRIs: Citalopram, Escitalopram, Duloxetine, Fluoxetine, Fluvoxamine, Levomilnacipran, Paroxetine, Venlafaxine, Vilazodone, Vortioxetine

## CASE REPORT

### Case 1. Acute liver injury due to sertraline.(1)

A 44 year old woman with mild reactive depression was treated with sertraline (50 mg daily) and developed fatigue followed by pruritus and jaundice 4-5 weeks later. She was also on levothyroxine and birth control pills which she had been taking for several years. She drank little alcohol and had no previous history of liver disease or known exposures to hepatitis. On presentation, she was jaundiced but had no fever or rash. Laboratory tests showed elevations in serum bilirubin and enzyme levels (Table), which were reported to have been normal in the past. She was admitted for evaluation; sertraline and the oral contraceptives were discontinued. Tests for hepatitis A, B and C were negative. There were low titers of antinuclear antibody (ANA 1:40), but no smooth muscle or mitochondrial antibodies. Abdominal ultrasound showed no evidence of biliary obstruction. She began to improve without specific therapy; jaundice resolved within 1 month, pruritus within 2 months and laboratory tests were normal at 6 months after presentation. Oral contraceptives were restarted without further incident.

#### Key Points

Medication: | Sertraline
Pattern: | Initially mixed (R=2.5), later cholestatic (R=1.2)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 1 month
Recovery: | 1-2 months symptomatically, 6 months biochemically
Other medications: | Birth control pills, levothyroxine

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
Sertraline taken for 5 weeks
1 month | 0 | 300 | 333 | 4.2 | Sertraline stopped
| 1 week | 236 | 299 | 5.1 | Ultrasound normal
| 2 weeks | 116 | 311 | 3.3
2 months | 4 weeks | 132 | 253 | 1.8
3 months | 2 months | 84 | 173 | 0.8
5 months | 4 months | 44 | Normal | 0.6
7 months | 6 months | Normal | Normal | 0.6
Normal Values | | <40 | <115 | <1.2

* Converted from times the upper limit of normal to U/L using normals provided.

#### Comment

More than 20 million prescriptions for sertraline are filled yearly in the United States, and therapy is typically long term. Nevertheless, cases of clinically apparent liver disease from sertraline are rare. This case was typical with an onset within 1 to 3 months of starting therapy and a somewhat prolonged course of cholestatic hepatitis, but with ultimate recovery. When patients develop acute liver injury from an SSRI, it is not clear whether another member of this group can be substituted. A structurally unrelated substitute along with careful monitoring is perhaps prudent if antidepressant therapy is considered necessary.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Sertraline – Generic, Zoloft®

DRUG CLASS

Antidepressant Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=sertraline)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Sertraline | 79617-96-2 | C17-H17-C12-N

## CITED REFERENCE

1 Hautekeete ML, Colle I, van Vlierberghe H, Elewaut A. (1998). Symptomatic liver injury probably related to sertraline. Gastroenterol Clin Biol.

## ANNOTATED BIBLIOGRAPHY

References updated: 08 April 2020

Abbreviations: MAO inhibitor, monoamine oxidase inhibitor; SSRI, selective serotonin reuptake inhibitor; SNRI, serotonin and norepinephrine reuptake inhibitor.

Zimmerman HJ. Antidepressants. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 493-8. (Expert review of hepatotoxicity published in 1999; reports that one case of acute drug-induced liver injury attributed to sertraline has been published).
Larrey D, Ripault MP. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 443-62. (Review of hepatotoxicity of antidepressants mentions that clinically apparent liver injury from the SSRIs is rare and sertraline has been implicated in only a few cases of severe hepatic injury).
O'Donnell JM, Bies RR, Shelton RC. Drug therapy of depression and anxiety disorders. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 267-77. (Textbook of pharmacology and therapeutics).
Doogan DP. (1991). Toleration and safety of sertraline: experience worldwide. Int Clin Psychopharmacol. (Rates of drug discontinuation for serum enzyme elevations were 0.5% for 1902 patients on sertraline vs 0.6% of 500 on active comparators and 0.0% of 666 on placebo; no cases of clinically apparent liver injury).
Menon RR, Howard R. (1994). Sertraline and liver toxicity in the elderly. Int J Geriatr Psychiatry. (Two cases of sertraline hepatotoxicity; 81 year old man had a rise in AST [36→98 U/L] and Alk P [78→452 U/L] without jaundice 3 weeks after starting sertraline, resolving within 2 months of stopping; 84 year old woman developed rise in ALT [1148 U/L] and Alk P [117→549 U/L], with subsequent multiorgan failure and death; few specific details given).
Hautekeete ML, Colle I, van Vlierberghe H, Elewaut A. (1998). Symptomatic liver injury probably related to sertraline. Gastroenterol Clin Biol. (44 year old woman developed jaundice, fatigue and itching 4-5 weeks after starting sertraline [bilirubin 4.2 mg/dL, ALT 7.5 times ULN, Alk P 2.9 times ULN], resolving within few months of stopping).
Mourilhe P, Stokes PE. (1998). Risks and benefits of selective serotonin reuptake inhibitors in the treatment of depression. Drug Saf. (Review of pharmacology, efficacy and safety of SSRIs; no mention of ALT elevations or hepatotoxicity).
Grohmann R, Rüther E, Engel RR, Hippius H. (1999). Assessment of adverse drug reactions in psychiatric inpatients with the AMSP drug safety program: methods and first results for tricyclic antidepressants and SSRI. Pharmacopsychiatry. (Analysis of reporting of adverse events among inpatients in 29 German hospitals between 1993 to 1997; 896 severe adverse events among 48,564 patients [1.8%], both total and hepatic events were more common with tricyclics than SSRIs).
Kim KY, Hwang W, Narendran R. (1999). Acute liver damage possibly related to sertraline and venlafaxine ingestion. Ann Pharmacother. (27 year old man took overdose of sertraline and cephalexin and had elevations of ALT to 1247 U/L, bilirubin 2.1 mg/dL; switched to venlafaxine, but 1 week later developed abdominal pain with bilirubin 1.6 mg/dL and ALT 814 U/L, improving on stopping but relapsing 3 days after restarting sertraline; recovered on stopping all SSRIs).
Verrico MM, Nace DA, Towers AL. (2000). Fulminant chemical hepatitis possibly associated with donepezil and sertraline therapy. J Am Geriatr Soc. (83 year old woman developed confusion and jaundice 4 months after starting sertraline and 10 days after starting donepezil [bilirubin 5.6 mg/dL, ALT 529 U/L and Alk P 369 U/L], resolving within 4 months of stopping both).
Fartoux-Heymann L, Hézode C, Zafrani ES, Dhumeaux D, Mallat A. (2001). Acute fatal hepatitis related to sertraline. J Hepatol. (54 year old man with alcoholism developed jaundice within 2 weeks of starting sertraline [bilirubin 10.5 mg/dL, ALT 906 U/L, Alk P 121 U/L, eosinophilia and prothrombin activity of 30%], and progressed to liver failure and death within 10 days, autopsy showing extensive necrosis without fat or Mallory bodies).
Galán Navarro JL. (2001). Rev Esp Enferm Dig. (57 year old woman developed jaundice and pruritus 8 weeks after starting sertraline [bilirubin 4.5 mg/dl, ALT 144 U/L, Alk P 1034 U/L], resolving within 6 months of stopping).
Carvajal García-Pando A, García del Pozo J, Sánchez AS, Velasco MA, Rueda de Castro AM, Lucena MI. (2002). Hepatotoxicity associated with the new antidepressants. J Clin Psychiatry. (Analysis of cases of hepatotoxicity from antidepressants in Spanish Pharmacovigilance System from 1989-1999, identified 99 cases; among SSRIs, 26 were due to fluoxetine, 14 paroxetine, 6 fluvoxamine, 5 sertraline, 3 venlafaxine and 2 citalopram; among tricyclics, 16 were due to clomipramine 7 amitriptyline, 6 imipramine; among miscellaneous, 3 were due to nefazodone and 1 trazodone; but all had a similar incidence=1-3 per 100,000 patient-years of exposure, except for nefazodone=29 per 100,000).
Lucena MI, Carvajal A, Andrade RJ, Velasco A. (2003). Antidepressant-induced hepatotoxicity. Expert Opin Drug Saf. (Review of hepatotoxicity of antidepressants; antidepressant use has increased markedly between 1992 and 2002, accounting for 5% of cases of hepatotoxicity; SSRIs are less likely to cause injury than tricyclics and MAO inhibitors; range of presentations, typically self-limited and rapid recovery; no hallmarks of hypersensitivity).
Persky S, Reinus JF. (2003). Sertraline hepatotoxicity: a case report and review of the literature on selective serotonin reuptake inhibitor hepatotoxicity. Dig Dis Sci. (23 year old woman developed fever and nausea during sertraline therapy [bilirubin 2.1 mg/dL, ALT ~850 U/L], resolving upon stopping and recurring [ALT~230 U/L] on restarting for 3 days).
Spigset O, Hägg S, Bate A. (2003). Hepatic injury and pancreatitis during treatment with serotonin reuptake inhibitors: data from the World Health Organization (WHO) database of adverse drug reactions. Int Clin Psychopharmacol. (Among 27,542 reports of hepatic injury in WHO database, 786 were related to SSRIs [3%], including citalopram 42, fluoxetine 222, fluvoxamine 54, paroxetine 191, sertraline 112, nefazodone 91 and venlafaxine 74; only nefazodone has an excess of hepatic reports in relationship to total reports).
Degner D, Grohmann R, Kropp S, Rüther E, Bender S, Engel RR, Schmidt LG. (2004). Severe adverse drug reactions of antidepressants: results of the German multicenter drug surveillance program AMSP. Pharmacopsychiatry. (Analysis of adverse drug reactions reported from 1993-2000 in 35 psychiatric hospitals; 0.7% of SSRI recipients had a severe adverse event; hepatic in 0.05%).
Solomons K, Gooch S, Wong A. (2005). Toxicity with selective serotonin reuptake inhibitors. Am J Psychiatry. (38 year old woman developed abdominal pain and ALT elevations [378 U/L] without jaundice 9 days after starting fluvoxamine; then had a positive rechallenge and recurrence with starting citalopram [ALT 379 within 4 days], and positive rechallenge with citalopram again 1 year later).
Pinzani V, Peyriere H, Hillaire-Buys D, Pageaux GP, Blayac BP, Larrey D. (2006). Specific serotonin recapture inhibitor (SSRI) antidepressants: hepatoxicity assessment in a large cohort in France. J Hepatol. (Abstract: Analysis of French Pharmacovigilance data on SSRIs found 63 cases of hepatotoxicity from paroxetine, 45 fluoxetine, 30 citalopram, 18 sertraline, and 2 fluvoxamine).
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. (2007). Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther. (Among 126 cases of drug induced liver injury seen in Spain between 1993-2000, 3 were attributed to paroxetine and 3 to fluoxetine, with a relative risk of injury to rate of use in the population of 3.0 and 1.8, respectively).
DeSanty KP, Amabile CM. (2007). Antidepressant-induced liver injury. Ann Pharmacother. (Review of drug induced liver injury and reports of injury from MAO inhibitors, SSRIs, tricyclics and atypical agents).
Collados Arroyo V, Plaza Aniorte J, Hallal H, Perez Cuadradob E. (2008). Farm Hosp. (47 year old man developed fatigue one month after starting sertraline [bilirubin 2.7 mg/dL, ALT 500 U/L, Alk P 377 U/L], resolving within 3 months of stopping).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 6 were attributed to duloxetine, 3 atomoxetine, 2 fluoxetine, 2 bupropion, and 1 sertraline as single agents).
Tabak F, Gunduz F, Tahan V, Tabak O, Ozaras R. (2009). Sertraline hepatotoxicity: report of a case and review of the literature. Dig Dis Sci. (17 year old boy developed jaundice 6 months after starting sertraline [bilirubin 2.1 mg/dL, ALT 1280 U/L, Alk P 483 U/L], resolving within 6 months of stopping).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, one was attributed to venlafaxine and one to fluoxetine but none to sertraline).
Collados V, Hallal H, Andrade RJ. (2010). Sertraline hepatotoxicity: report of a case and review of the literature. Dig Dis Sci. (Review of published cases of sertraline hepatotoxicity mentions 4 cases [bilirubin 2.6 to 10.5 mg/dL, ALT 144-906 U/L, Alk P 121-1034 U/L], one fatal and three resolving within 3-6 months).
García-Aparicio J, Herrero-Herrero JI. (2010). Farm Hosp. (65 year old woman developed jaundice several weeks after receiving several antibiotics and 15 days after starting sertraline [bilirubin 3.5 mg/dL, ALT 937 U/L, Alk P 373 U/L], resolving within 3 months of stopping sertraline).
Molleston JP, Fontana RJ, Lopez MJ, Kleiner DE, Gu J, Chalasani N. (2011). Drug-induced Liver Injury Network. Characteristics of idiosyncratic drug-induced liver injury in children: results from the DILIN prospective study. J Pediatr Gastroenterol Nutr. (Among 30 children with suspected drug induced liver injury, half [n=15] were due to antimicrobials [minocycline 4, INH 3, azithromycin 3] and the rest largely due to CNS agents and anticonvulsants; one case was attributed to amitriptyline, but sertraline was not listed).
Park SH, Ishino R. (2013). Liver injury associated with antidepressants. Curr Drug Saf. (Review of antidepressant induced liver injury).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to sertraline even though it is ranked as one of the top 20 most prescribed medications in Iceland).
Suen CF, Boyapati R, Simpson I, Dev A. (2013). Acute liver injury secondary to sertraline. BMJ Case Rep. (26 year old pregnant woman developed nausea and dark urine 24 weeks after starting and 3 weeks after increasing the dose of sertraline [bilirubin 1.5 mg/dL, ALT 700 U/L, Alk P 113 U/L, INR normal], resolving within 80 days of stopping and subsequent normal delivery).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, only one of which was attributed to an antidepressant [amitriptyline] and none to a MAO inhibitor, SSRI or SNRI).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al. (2015). United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 20 cases [2%] were attributed to antidepressants including 9 due to SNRIs [7 to duloxetine, 1 each to nefazodone and trazodone], 5 to bupropion, 5 to SSRIs [3 to escitalopram, and 1 each to fluoxetine and sertraline], and only 1 to tricyclics [imipramine]).
Freiesleben SD, Furczyk K. (2015). A systematic review of agomelatine-induced liver injury. J Mol Psychiatry. (Review of the literature on liver injury associated with agomelatine therapy concludes that serum ALT levels arise more frequently during agomelatine compared to placebo treatment, but that similar rates of enzyme elevations are found with many other antidepressants).
Voican CS, Martin S, Verstuyft C, Corruble E, Perlemuter G, Colle R. (2016). Liver function test abnormalities in depressed patients treated with antidepressants: a real-world systematic observational study in psychiatric settings. PLoS One. (Among 321 psychiatric inpatients, only 116 [36%] had liver tests performed and only 18 during therapy with an antidepressant, 3 of which were suspected to have drug induced liver injury, 1 each with escitalopram, venlafaxine and amitriptyline, all without jaundice and 2 without symptoms, all 3 resolving).
Friedrich ME, Akimova E, Huf W, Konstantinidis A, Papageorgiou K, Winkler D, Toto S, et al. (2016). Drug-induced liver injury during antidepressant treatment: results of AMSP, a drug surveillance program. Int J Neuropsychopharmacol. (Among 184,234 psychiatric inpatients from 80 hospitals, 149 cases [0.08%] of drug induced liver injury were reported including 22 of 70,060 [0.03%] receiving SSRIs, 71 of 50,201 [0.14%] patients treated with tricyclics and 3 of 3869 receiving MAO inhibitors [0.08%]).
Gahr M, Zeiss R, Lang D, Connemann BJ, Hiemke C, Schönfeldt-Lecuona C. (2016). Drug-Induced liver injury associated with antidepressive psychopharmacotherapy: an explorative assessment based on quantitative signal detection using different MedDRA terms. J Clin Pharmacol. (Using data on adverse drug reaction reports from the Uppsala Monitoring Center of WHO, there were higher relative hepatotoxicity reports for nefazodone, agomelatine, many tricyclics and mirtazapine).
Conrad MA, Cui J, Lin HC. (2016). Sertraline-associated cholestasis and ductopenia consistent with vanishing bile duct syndrome. J Pediatr. (15 year old developed jaundice and itching 5 months after starting sertraline [bilirubin 8.0 rising to 33.7 mg/dL, ALT 238 U/L, GGT 36], with a delay in stopping until a liver biopsy showed cholestatic hepatitis, slow to resolving, but all tests were normal 4 months later).
Nicoletti P, Aithal GP, Bjornsson ES, Andrade RJ, Sawle A, Arrese M, Barnhart HX, et al., International Drug-Induced Liver Injury Consortium, Drug-Induced Liver Injury Network Investigators, and International Serious Adverse Events Consortium. (2017). Association of liver Injury from specific drugs, or groups of drugs, with polymorphisms in HLA and other genes in a genome-wide association study. Gastroenterology. (A genome wide association study done on 862 patients with drug induced liver injury found several associations within the HLA region, most striking was HLA-A*33:01 with an allele frequency of 0.01 in Caucasian controls and 0.02 in drug induced liver injury patients [0.01 with hepatocellular and 0.04 with cholestatic injury], particularly frequent with injury due to ticlopidine [in 4 of 5 cases], methyldopa [2 or 4], fenofibrate [4 of 7], terbinafine [6 of 14], enalapril [2 or 4], sertraline [2 of 5] and erythromycin [2 of 10]).
Chen VC, Lin CF, Hsieh YH, Liang HY, Huang KY, Chiu WC, Lee Y, McIntyre RS, et al. (2017). Hepatocellular carcinoma and antidepressants: a nationwide population-based study. Oncotarget. (Among almost 50,000 cases of hepatocellular carcinoma registered in the Taiwan National Health Insurance Research Database, the rate of antidepressant use was lower than in approximately 250,000 matched controls from the database).
Osorio S, Escudero-Vilaplana V, Reguilón-Gallego L, Gómez-Centurión I, Díez JL, Ferrer-Marín F. (2017). Severe liver toxicity in a chronic myeloid leukemia patient probably induced by a drug interaction between imatinib and sertraline. J Oncol Pharm Pract. (43 year old man with chronic myelogenous leukemia developed liver injury 4 months after starting imatinib and 5 weeks after starting sertraline [bilirubin 1.0 rising to 10 mg/dL, ALT 791 U/L, Alk P 457 U/L] worsened for 2 weeks despite stopping both drugs and then began to improve; after recovery the leukemia relapsed and he was started on dasatinib without recurrence of liver injury).
Thébaut A, Habes D, Gottrand F, Rivet C, Cohen J, Debray D, Jacquemin E, et al. (2017). Sertraline as an additional treatment for cholestatic pruritus in children. J Pediatr Gastroenterol Nutr. (Among 20 children with pruritis due to liver disease treated with sertraline [1-4 mg/kg/day], pruritis improved in 14 who were maintained on therapy long term, while bile acid and bilirubin levels did not change and there were no serious adverse events or mention of worsening of ALT levels or hepatotoxicity).
Ferrajolo C, Scavone C, Donati M, Bortolami O, Stoppa G, Motola D, Vannacci A, et al., DILI-IT Study Group. (2018). Antidepressant-induced acute liver injury: a case-control study in an Italian inpatient population. Drug Saf. (Among 179 cases of hospitalizations for unexplained acute liver injury enrolled in an Italian prospective study between 2010 and 2014, 17 had been exposed to antidepressants the major implicated agents being citalopram [n=4], sertraline [n=3], paroxetine [n=3], tricyclics [n=2], trazodone [n=1], fluoxetine [n=1], and duloxetine [n=1]; no MAO inhibitors listed).
Billioti de Gage S, Collin C, Le-Tri T, Pariente A, Bégaud B, Verdoux H, Dray-Spira R, et al. (2018). Antidepressants and hepatotoxicity: a cohort study among 5 million individuals registered in the French National Health Insurance Database. CNS Drugs. (Among 5 million persons identified in a national French health insurance database who started an antidepressant between 2010 and 2015, 382 developed serious liver injury resulting in hospitalization, rates per 100,0000 persons-years being 19 for SSRIs, 22 venlafaxine, 13 duloxetine, and 33 mirtazapine).
Chan HL, Chiu WC, Chen VC, Huang KY, Wang TN, Lee Y, McIntyre RS, et al. (2018). SSRIs associated with decreased risk of hepatocellular carcinoma: A population-based case-control study. Psychooncology. (Analysis of the Taiwan National Health Service Insurance Research Database identified 59,859 patients with initial diagnosis of hepatocellular carcinoma and 285,124 matched controls; SSRI [including sertraline] use was more frequent in the controls than in the HCC cases but only in analyses adjusted for possibly confounding factors).
Lochmann D, Richardson T. (2019). Selective serotonin reuptake inhibitors. Handb Exp Pharmacol. (Overview of the SSRIs mentioned that they have similar efficacy in treating depression and similar rates and adverse event profile which largely represents the effects of serotonin excess: nausea, diarrhea, dizziness, somnolence, insomnia, sweating, tremor anxiety, dry mouth, anxiety and restlessness; they can also cause weigh gain and sex dysfunction as well as activate mania and cause withdrawn symptoms).
Tejedor-Tejada J, García-Pajares F, Madrigal Rubiales B. (2019). Hepatobiliary and Pancreatic: Sertraline-induced vanishing bile duct syndrome treated with plasmapheresis. J Gastroenterol Hepatol. (39 year old woman developed jaundice 15 weeks after starting sertraline [bilirubin not given, ALT ~370 U/L, GGT ~220 rising to 920 U/L), biopsy showing bile duct paucity and slow but eventual full recovery after stopping).
(2019). Drugs for anxiety disorders. Med Lett Drugs Ther. (Concise review of drugs for anxiety including SSRIs, SNRIs and benzodiazepines including mechanism of action, clinical efficacy, safety and costs; does not mention ALT elevations or hepatotoxicity).
(2020). Drugs for depression. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of drugs for depression; hepatotoxicity is mentioned only for nefazodone [now rarely used because of severe hepatotoxicity] and duloxetine [in heavy drinkers]).
Ueberberg B, Frommberger U, Messer T, Zwanzger P, Kuhn J, Anghelescu I, Ackermann K, Assion HJ. (2020). Drug-induced liver injury (DILI) in patients with depression treated with antidepressants: a retrospective multicenter study. Pharmacopsychiatry. (Among 329 psychiatric inpatients with depression seen at 6 psychiatric centers in Germany, 17 [5%] had serum aminotransferase elevations but none had clinically apparent liver injury, most commonly implicated drugs included mirtazapine, agomelatine, citalopram and venlafaxine).

## OTHER REFERENCE LINKS

1 Recent References on Sertraline: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(sertraline)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Sertraline: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=sertraline)